# Brexpiprazole

## OVERVIEW

### Introduction

Brexpiprazole is an atypical antipsychotic used in the treatment of schizophrenia and major depressive disorders. Brexpiprazole has been associated with a low rate of serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent acute liver injury.

### Background

Brexpiprazole (brex pip' ra zole) is a second generation (atypical) antipsychotic agent that is similar in structure and mechanism of action to aripiprazole. These two agents are believed to act as partial antagonists of dopamine type 2 (D2) and serotonin (5-HT)-2A receptors and partial agonists of serotonin 5-HT-1A receptors. In several randomized controlled trials, therapy with brexpiprazole was associated with a lessening of symptoms of schizophrenia and improvement in depression symptom scores in comparison to placebo treatment. It was approved for use in the United States in 2015 as therapy for schizophrenia and as adjunctive therapy with antidepressants for major depressive disorders. Brexpiprazole is available as tablets of 0.25, 0.5, 1, 2, 3 and 4 mg generically and under the brand name Rexulti. The standard maintenance dose for schizophrenia in adults is 2 to 4 mg daily. The dose for as an adjunctive therapy for major depression is usually less. Common side effects include restlessness (akathisia), sedation, tremor, dizziness, blurred vision, fatigue, headaches, nausea and weight gain. Rare, but potential severe adverse reactions (mentioned in most antipsychotic product labels) include tardive dyskinesia, major neurologic events, neuroleptic malignant syndrome, orthostatic hypotension, seizures and neutropenia. Like many antipsychotic medications, brexpiprazole has a boxed warning for excessive mortality in elderly patients with dementia-related psychosis and, like many antidepressants, it also has a boxed warning for increased risk of suicidal thoughts and behaviors.

### Hepatotoxicity

Liver test abnormalities were reported to occur in ~1% of patients on long term therapy with brexpiprazole, but similar rates occurred in patients on placebo or with comparator agents. There have been no published reports of clinically apparent acute liver injury due to brexpiprazole and only rare instances have been reported with the much more frequently used aripiprazole. Thus, liver injury due to brexpiprazole must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Brexpiprazole is extensively metabolized by the liver via the P450 system, largely by CYP 3A4 and 2D6, and liver injury from its use might be caused by a toxic or immunogenic intermediate metabolite. Brexpiprazole, like aripiprazole, is susceptible to drug-drug interactions, strong inducers of CYP 3A4 (such as rifampin) resulting in lower drug levels, and strong inhibitors (such as ketoconazole) resulting in higher levels.

### Outcome and Management

The serum aminotransferase elevations that occur with brexpiprazole therapy are usually self-limited and often do not require dose modification or discontinuation. No instances of acute liver failure, chronic hepatitis or vanishing bile duct syndrome have been attributed to brexpiprazole. Cross sensitivity to liver related or other hypersensitivity reactions between brexpiprazole and other antipsychotic agents have not been demonstrated but might be expected to occur with aripiprazole.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Brexpiprazole – Generic, Rexulti®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Brexpiprazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Aripiprazole | 129722-12-9 | C23-H27-Cl2-N3-O2
Brexpiprazole | 913611-97-9 | C25-H27-N3-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2015/205422Orig1Orig2s000MedR.pdf (FDA website with product labels and medical review of studies of brexpiprazole in support of its approval; mentions that in preregistration trials of brexpiprazole for schizophrenia, ALT elevations arose in 0.3% of patients on 2 mg daily and 1.4% of those on higher doses versus 0.5% on placebo, and there were no cases of clinically apparent liver injury with jaundice).
Leucht S, Corves C, Arbter D, Engel RR, Li C, Davis JM. (2009). Second-generation versus first-generation antipsychotic drugs for schizophrenia: a meta-analysis. Lancet. (Systematic review of efficacy and safety of newer antipsychotic agents including aripiprazole, but not brexpiprazole; no discussion of liver related side effects or ALT elevations).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including four due to psychotropic agents; one each for quetiapine, nefazodone, fluoxetine and venlafaxine, but none for aripiprazole or brexpiprazole or other second generation antipsychotic agent).
(2015). Brexpiprazole (Rexulti) for schizophrenia and depression. Med Lett Drugs Ther. (Brief review of efficacy and safety of brexpiprazole shortly after its approval in the US; frequent side effects are anxiety, headache, nausea, constipation, insomnia, dizziness and somnolence; has little effect on weight; no mention of hepatotoxicity or effect on ALT levels).
Kane JM, Skuban A, Ouyang J, Hobart M, Pfister S, McQuade RD, Nyilas M, et al. (2015). A multicenter, randomized, double-blind, controlled phase 3 trial of fixed-dose brexpiprazole for the treatment of adults with acute schizophrenia. Schizophr Res. (Among 674 adults with acute schizophrenia treated with brexpiprazole [1, 2 or 4 mg daily] or placebo for 6 weeks, improvements in symptom scores were greater with brexpiprazole than placebo and side effects included weight gain [1.5 vs 0.35 kg]; no mention of ALT elevations or hepatotoxicity).
Correll CU, Skuban A, Ouyang J, Hobart M, Pfister S, McQuade RD, Nyilas M, et al. (2015). Efficacy and safety of brexpiprazole for the treatment of acute schizophrenia: a 6-week randomized, double-blind, placebo-controlled trial. Am J Psychiatry. (Among 636 adults with an acute exacerbation of schizophrenia treated with 1 or 3 doses of brexpiprazole [0.25, 2 or 4 mg daily] or placebo for 6 weeks, symptom scores improved more with brexpiprazole, and adverse events included restlessness [akathisia] and weight gain, while discontinuations due to liver test elevations occurred equally with drug and placebo [1.1%]).
Citrome L. (2015). Brexpiprazole: a new dopamine D2 receptor partial agonist for the treatment of schizophrenia and major depressive disorder. Drugs Today (Barc). (Systematic review of results of 4 phase III trials and subsequent extension studies of brexpiprazole in schizophrenia and major depressive disorders reported overall improvements in symptom scores with treatment, and an increase in adverse events in comparison to placebo of restlessness [5-10%], weight gain [5-30%]; no mention of ALT elevations or hepatotoxicity).
Thase ME, Youakim JM, Skuban A, Hobart M, Augustine C, Zhang P, McQuade RD, et al. (2015). Efficacy and safety of adjunctive brexpiprazole 2 mg in major depressive disorder: a phase 3, randomized, placebo-controlled study in patients with inadequate response to antidepressants. J Clin Psychiatry. (Among 353 patients with major depressive disorders on conventional antidepressants who were treated with brexpiprazole [2 mg daily] or placebo for 6 weeks, depression scores improved more with brexpiprazole and adverse events included restlessness [7%] and weight gain [8%]; no mention of ALT elevations or hepatotoxicity).
Thase ME, Youakim JM, Skuban A, Hobart M, Augustine C, Zhang P, McQuade RD, et al. (2015). Efficacy and safety of adjunctive brexpiprazole 2 mg in major depressive disorder: a phase 3, randomized, placebo-controlled study in patients with inadequate response to antidepressants. J Clin Psychiatry. (Among 353 adults with major depressive disorder with an inadequate response to antidepressants treated with addition of brexpiprazole [2 mg daily] or placebo for 6 weeks, depression symptom scores improved more with brexpiprazole than placebo, while adverse events included weight gain [8% vs 3.1%] and akathisia [7.4% vs 1%], but routine laboratory test results did not differ between the two groups).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Fleischhacker WW, Hobart M, Ouyang J, Forbes A, Pfister S, McQuade RD, Carson WH, et al. (2017). Efficacy and safety of brexpiprazole (OPC-34712) as maintenance treatment in adults with schizophrenia: a randomized, double-blind, placebo-controlled study. Int J Neuropsychopharmacol. (Among 202 patients with schizophrenia who were stabilized on brexpiprazole for 12 weeks and then continued treatment or were switched to placebo, relapse rates were lower with drug continuation [13.5% vs 38.5%] as were adverse event rates; no mention of ALT elevations or hepatotoxicity).
Hobart M, Skuban A, Zhang P, Augustine C, Brewer C, Hefting N, Sanchez R, McQuade RD. A Randomized, placebo-controlled study of the efficacy and safety of fixed-dose brexpiprazole 2 mg/d as adjunctive treatment of adults with major depressive disorder. J Clin Psychiatry. 2018;79:17m12058. (Among 393 patients with major depressive disorder with inadequate response to antidepressants who were treated with addition of brexpiprazole [2 mg] or placebo daily for 6 weeks, changes in depression rating scores were greater with brexpiprazole, while adverse event rates were higher [60% vs 50%] including weight gain [1.5 vs 0.5 kg], akathisia [8% vs 2%], restlessness [8% vs 2%], insomnia [5% vs 1%], and fatigue [2.6% vs 0.5%], but there were no differences in changes in laboratory test results; no specific mention of ALT elevations or hepatotoxicity).
Forbes A, Hobart M, Ouyang J, Shi L, Pfister S, Hakala M. (2018). A long-term, open-label study to evaluate the safety and tolerability of brexpiprazole as maintenance treatment in adults with schizophrenia. Int J Neuropsychopharmacol. (Among 1072 adults with schizophrenia treated with controlled trials of brexpiprazole who were enrolled in a 52 week, open label extension study [flexible dose: 1-4 mg/day], adverse events included relapse of schizophrenia, weight gain [mean +2.1 kg at 52 weeks], headache, agitation, and akathisia; no mention of ALT elevations or hepatotoxicity).
Hobart M, Zhang P, Skuban A, Brewer C, Hefting N, Sanchez R, McQuade RD. (2019). A long-term, open-label study to evaluate the safety and tolerability of brexpiprazole as adjunctive therapy in adults with major depressive disorder. J Clin Psychopharmacol. (Among 2944 patients with major depressive disorder participating in controlled trials of brexpiprazole who were enrolled in a 52 week open label extension study [flexible dose: 0.5 to 3 mg/day], the antidepressant effects were sustained and adverse events included weight gain [2.6 kg at 24 weeks], somnolence, headache, akathisia, increased appetite, and anxiety; no mention of ALT levels or hepatotoxicity).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise summary of the mechanisms of action, clinical efficacy, safety and costs of the drugs approved for depression in the US; mentions that some antipsychotic agents are used to augment the effect of standard antidepressants in patients with major depressive disorders; no discussion of hepatotoxicity).
Grossberg GT, Kohegyi E, Mergel V, Josiassen MK, Meulien D, Hobart M, Slomkowski M, et al. (2020). Efficacy and safety of brexpiprazole for the treatment of agitation in Alzheimer's dementia: two 12-week, randomized, double-blind, placebo-controlled trials. Am J Geriatr Psychiatry. (Among 703 patients with Alzheimer dementia and agitation treated with brexpiprazole in two 12-week controlled trials, a decrease in agitation was found with higher doses of brexpiprazole [2-4 mg/day]; there were no hepatic serious adverse events or deaths from liver disease; no mention of ALT elevations).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).

## OTHER REFERENCE LINKS

1 Recent References on Brexpiprazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Brexpiprazole/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Brexpiprazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Brexipiprazole)